# Amisulpride

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Amisulpride is an intravenously administered dopamine receptor 2 antagonist used for the prevention and therapy of postoperative nausea and vomiting. Amisulpride when given in single doses intravenously has not been associated with serum aminotransferase elevations or with instances of clinically apparent liver.

### Background

Amisulpride (a” mi sul’ pride) is a dopamine receptor type 2 (DR2) antagonist used for the prevention and therapy of postoperative nausea and vomiting. Amisulpride blocks dopamine receptors found in the chemoreceptor trigger zone in the hypothalamus that relays stimuli to the vomiting center. In several controlled trials, administration of a single intravenous dose of amisulpride at the time of induction of anesthesia for surgery reduced nausea and vomiting during the 24 to 48 hours thereafter. Similarly, administration of a single intravenous dose after onset of nausea reduced the frequency and severity of subsequent nausea and vomiting. Amisulpride can be given orally and is approved as an oral antipsychotic medication in Europe, but not in the United States. Intravenously administered amisulpride was approved in the United States in 2020 for prevention of postoperative nausea and vomiting either alone or in combination with an antiemetic of a different class or for treatment of postoperative nausea and vomiting in patients who did not receive preventive therapy or received another class of antiemetics. Amisulpride is available in solution for intravenous administration in vials of 2 and 4 mL (2.5 mg/mL) under the brand name Barhemsys. The recommended dose for prevention is 5 mg (2 mL) and for therapy of nausea and vomiting is 10 mg (4 mL). Amisulpride given in a single intravenous dose has few adverse events. While oral amisulpride, like other dopamine receptor antagonists, has been linked to rare instances of extrapyramidal side effects and neuroleptic malignant syndrome, these severe adverse events have not been found to be associated with its use in single doses given intravenously. Amisulpride has been linked to prolongation of the QTc interval and should be avoided in patients with known prolonged QTc intervals or in patients receiving other agents that can prolong the QTc interval as well as other dopamine antagonists.

### Hepatotoxicity

Intravenous single doses of amisulpride are generally well tolerated, and in multiple randomized controlled trials were not associated with rates of serum aminotransferase or bilirubin elevations above those that occurred in placebo treated subjects. While oral amisulpride has been linked to transient serum aminotransferase elevations during therapy, single intravenous doses of amisulpride have not been linked to liver enzyme elevations in excess of rates found postoperatively. Since its approval and more widespread use, amisulpride has not been implicated in cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible mechanism of liver injury from amisulpride is not known, but liver test abnormalities can occur with prolonged oral dosing. Oral amisulpride can also cause extrapyramidal symptoms and neuroleptic malignant syndrome, probably due to excessive dopamine receptor antagonism. Amisulpride is not metabolized to a great extent by the liver, is not a substrate of the P450 system, and has no interaction with CYP enzyme activities.

Drug Class: Gastrointestinal Agents, Antiemetic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amisulpride – Barhemsys®

DRUG CLASS

Antiemetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amisulpride)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amisulpride | 71675-85-9 | C17-H27-N3-O4-S

## BIBLIOGRAPHY

References updated: 28 April 2024

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/209510Orig1s000MultidisciplineR.pdf (FDA integrated review of the data on safety and efficacy of intravenous amisulpride submitted in support of the application for approval as therapy of postoperative nausea and vomiting states that among 1924 patients who received amisulpride there were “no clinically important changes in clinical chemistry values between baseline and post operation” and that extrapyramidal symptoms were uncommon and mild, and rates were similar between placebo and amisulpride treated patients).
Coulouvrat C, Dondey-Nouvel L. Safety of amisulpride (Solian): a review of 11 clinical studies. Int Clin Psychopharmacol. 1999;14:209-18.10468313
Mortimer A, Martin S, Lôo H, Peuskens J; SOLIANOL Study Group. A double-blind, randomized comparative trial of amisulpride versus olanzapine for 6 months in the treatment of schizophrenia. Int Clin Psychopharmacol. 2004;19:63-9.15076013
Musshoff F, Doberentz E, Madea B. Lethal neuroleptic malignant syndrome due to amisulpride. Forensic Sci Med Pathol. 2013;9:218-20.23504701
Gan TJ, Kranke P, Minkowitz HS, Bergese SD, Motsch J, Eberhart L, Leiman DG, et al. Intravenous amisulpride for the prevention of postoperative nausea and vomiting: two concurrent, randomized, double-blind, placebo-controlled trials. Anesthesiology. 2017;126:268-275.27902493
Kranke P, Bergese SD, Minkowitz HS, Melson TI, Leiman DG, Candiotti KA, Liu N, Eberhart L, Habib AS, Wallenborn J, Kovac AL, Diemunsch P, Fox G, Gan TJ. Amisulpride Prevents Postoperative Nausea and Vomiting in Patients at High Risk: A Randomized, Double-blind, Placebo-controlled Trial. Anesthesiology. 2018 Jun;128(6):1099-1106.29543631
Habib AS, Kranke P, Bergese SD, Chung F, Ayad S, Siddiqui N, Motsch J, et al. Amisulpride for the Rescue Treatment of Postoperative Nausea or Vomiting in Patients Failing Prophylaxis: A Randomized, Placebo-controlled Phase III Trial. Anesthesiology. 2019;130:203-212.30475232
Candiotti KA, Kranke P, Bergese SD, Melson TI, Motsch J, Siddiqui N, Chung F, et al. Randomized, Double-Blind, Placebo-Controlled Study of Intravenous Amisulpride as Treatment of Established Postoperative Nausea and Vomiting in Patients Who Have Had No Prior Prophylaxis. Anesth Analg. 2019;128:1098-1105.31094774
Herrstedt J, Summers Y, Jordan K, von Pawel J, Jakobsen AH, Ewertz M, Chan S, et al. Amisulpride prevents nausea and vomiting associated with highly emetogenic chemotherapy: a randomised, double-blind, placebo-controlled, dose-ranging trial. Support Care Cancer. 2019;27:2699-2705.30488222
IV Amisulpride (Barhemsys) for postoperative nausea and vomiting. Med Lett Drugs Ther. 2020;62:205-208.33451177
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. 2022;42:440-444.35730552

## OTHER REFERENCE LINKS

1. Recent References on Amisulpride: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Amisulpride+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Amisulpride: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Amisulpride)